# Baricitinib

## OVERVIEW

### Introduction

Baricitinib is an orally available small molecule inhibitor of Janus kinases that is used to treat moderate-to-severe rheumatoid arthritis, severe alopecia areata, and, in combination with remdesivir, severe COVID-19 in hospitalized patients requiring supplementary oxygen. Baricitinib is associated with transient and usually mild elevations in serum aminotransferase levels during therapy but has yet to be linked to cases of clinically apparent acute liver injury.

### Background

Baricitinib (bar" i sye' ti nib) is an orally available, specific inhibitor Janus-associated kinases (mainly JAK1 and JAK2) that is used to treat moderate-to-severe rheumatoid arthritis and alopecia areata. The Janus kinases are critical steps in immune activation as well as in hematopoiesis. JAK1 is a critical kinase in the cellular responses of interferon alpha while JAK2 is involved in pathways activated by interferon gamma. The immunomodulatory effects of baricitinib have led to its evaluation in several autoimmune conditions including rheumatoid arthritis, psoriasis and alopecia areata. In multiple randomized controlled trials, baricitinib was found to improve symptoms and signs of severe rheumatoid arthritis when used alone or in combination with other disease modifying anti-rheumatologic drugs (DMARDs). Baricitinib was approved for use in rheumatoid arthritis in the United States in 2018, the third small molecule JAK inhibitor to receive approval (after tofacitinib in 2012 and ruxolitinib in 2011). Indications for baricitinib were extended to moderate-to-severe alopecia areata in 2022. Baricitinib is also under evaluation as therapy for other autoimmune conditions including psoriasis and atopic dermatitis. Baricitinib is available in tablets of 1, 2 and 4 mg under the brand name Olumiant. The recommended dose in rheumatoid arthritis is 2 mg once daily. Common side effects are nausea, diarrhea, fatigue, neutropenia, elevations in serum levels of cholesterol and creatinine, herpes simplex and zoster infections, and symptoms of upper respiratory tract infection. Rare but potentially severe adverse events may include severe infections, reactivation of latent tuberculosis, increased risk of malignancy, gastrointestinal perforation, major adverse cardiovascular events (myocardial infarction, cardiac death or stroke) and vascular thromboses.

In November 2020, baricitinib was given emergency use authorization in combination with remdesivir as therapy of adults and children above the age of 2 who are hospitalized with confirmed COVID-19 infection and require supplementary oxygen, mechanical ventilation or extracorporeal membrane oxygenation. Preliminary trials of baricitinib in patients with severe COVID-19 pneumonia given in combination with remdesivir suggested that it shortened the time to recovery and reduced morbidity. Further trials have subsequently supported these results. This indication was given full FDA approval in adults in 2022. The recommended dose regimen in adults is 4 mg orally once daily for 14 days or until hospital discharge.

### Hepatotoxicity

In the large prelicensure clinical trials in rheumatoid arthritis, serum aminotransferase elevations occurred in up to 17% of baricitinib treated subjects compared to 11% in placebo recipients. The elevations were typically mild and transient and values above 3 times the upper limit of normal (ULN) occurred in 1% to 2% of patients. The elevations occasionally led to early discontinuations, but more often resolved even without dose adjustment. In prelicensure studies in rheumatoid arthritis, alopecia areata and other rheumatic and immune-mediated disorders, there were no instances of clinically apparent liver injury attributed to baricitinib. Since approval and more wide scale availability of baricitinib, there have been no published reports of hepatotoxicity associated with its use.

Use of baricitinib in combination with remdesivir for severe COVID-19 pneumonia has been reported but with little information on its potential for causing liver injury. Patients with severe SARS-CoV-2 infection frequently have elevated serum aminotransferase levels and occasionally are jaundiced. Furthermore, remdesivir has been linked to serum aminotransferase elevations during therapy that are generally mild-to-moderate in severity and resolve rapidly once the drug is stopped. Whether baricitinib increases the risk of liver injury during COVID-19 has yet to be shown, but hepatotoxicity was not a prominent feature in these early studies of its use in patients with severe COVID-19.

Finally, baricitinib is an immune modulatory agent and has the potential of causing reactivation of viral infections including hepatitis B. In clinical trials, patients with HBsAg in serum were excluded from enrollment but patients with anti-HBc without HBsAg were allowed. While routine monitoring for reactivation was not performed on all patients, at least 15% of anti-HBc positive persons with rheumatoid arthritis treated with baricitinib developed virologic evidence of reactivation marked by de novo appearance of low levels of HBV DNA in serum. In all cases, the period of viremia was brief and not associated with serum aminotransferase elevations or jaundice. Thus, baricitinib appears to be capable of causing HBV reactivation but it is generally subclinical. Furthermore, the short courses of baricitinib used in the treatment of severe COVID-19 have not been linked to episodes of HBV reactivation.

Likelihood score: E* (unlikely to be a cause of idiosyncratic clinically apparent liver injury but has the potential to cause reactivation of hepatitis B).

### Mechanism of Injury

The cause of mild serum enzyme elevations during baricitinib therapy is not known. Baricitinib is largely excreted unchanged in urine and stool and less than 10% undergoes hepatic metabolism, largely via CYP 3A4. The metabolism of baricitinib is not affected by CYP inhibitors or inducers, but its renal excretion can be affected by probenecid.

### Outcome and Management

Monitoring of serum aminotransferase levels is recommended for patients starting baricitinib. De novo elevations in serum aminotransferases levels above 5 times the upper limit of normal should lead to temporary cessation. If serum enzyme elevations do not resolve or improve within a few weeks of stopping, or if symptoms of liver injury or jaundice arise, baricitinib should be permanently discontinued. There does not appear to be cross reactivity in risk for hepatic injury between baricitinib and tofacitinib or other biologic or non-biologic DMARDs. Because of its potential to cause reactivation of hepatitis B, routine screening for HBsAg and anti-HBc is appropriate before starting therapy with baricitinib. Patients with HBsAg in serum should be treated prophylactically with an oral antiviral agent with activity against HBV such as entecavir or tenofovir. An alternative is to monitor patients carefully for HBV DNA levels to detect evidence of reactivation early and initiate appropriate therapy for HBV infection.

Drug Class: Antirheumatic Agents, Protein Kinase Inhibitors, COVID-19 Drugs

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Baricitinib – Olumiant®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Baricitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Baricitinib | 1187594-09-7 | C16-H17-N7-O2-S
Tofacitinib | 477600-75-2 | C16-H20-N6-O

## ANNOTATED BIBLIOGRAPHY

References updated: 30 August 2022

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as tofacitinib and baricitinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not baricitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics; baricitinib is not discussed).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/207924Orig1s000SumR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
van Vollenhoven RF, Fleischmann R, Cohen S, Lee EB, García Meijide JA, Wagner S, Forejtova S, et al., ORAL Standard Investigators. (2012). Tofacitinib or adalimumab versus placebo in rheumatoid arthritis. N Engl J Med. (Among 717 patients with rheumatoid arthritis on methotrexate treated with tofacitinib [5 or 10 mg] or adalimumab or placebo for 52 weeks, clinical response rates were higher for tofacitinib [52-53%] than placebo [28%] and adverse events were more common [with two cases of pulmonary tuberculosis]; ALT elevations during the first 3 months occurred in 26% on tofacitinib vs 17% on placebo).
Fleischmann R, Kremer J, Cush J, Schulze-Koops H, Connell CA, Bradley JD, Gruben D, et al., ORAL Solo Investigators. (2012). Placebo-controlled trial of tofacitinib monotherapy in rheumatoid arthritis. N Engl J Med. (Among 611 patients with rheumatoid arthritis treated with tofacitinib [5 or 10 mg] or placebo twice daily for 3 months, clinical response rates were higher with tofacitinib, and adverse events included headache, infections, neutropenia and increases in serum cholesterol; ALT elevations above 3 times ULN occurred during the first 3 months in <1% of both groups).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; baricitinib and tofacitinib are not discussed).
Spraggs CF, Xu CF, Hunt CM. (2013). Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; baricitinib and tofacitinib is not mentioned).
Keystone EC, Taylor PC, Drescher E, Schlichting DE, Beattie SD, Berclaz PY, Lee CH, et al. (2015). Safety and efficacy of baricitinib at 24 weeks in patients with rheumatoid arthritis who have had an inadequate response to methotrexate. Ann Rheum Dis. (Among 301 patients with rheumatoid arthritis and an inadequate response to methotrexate treated with baricitinib [1, 2, 4 or 8 mg] or placebo daily for 12 weeks, clinical response rates were higher with the higher doses of baricitinib, while rates of ALT elevations were similar in all groups and no patient suffered a liver related serious adverse event).
Papp KA, Menter MA, Abe M, Elewski B, Feldman SR, Gottlieb AB, Langley R, et al. (2015). OPT Pivotal 1 and OPT Pivotal 2 investigators. Tofacitinib, an oral Janus kinase inhibitor, for the treatment of chronic plaque psoriasis: results from two randomized, placebo-controlled, phase III trials. Br J Dermatol. (Among 1861 patients with plaque psoriasis treated with tofacitinib [5 or 10 mg] or placebo twice daily for 16 weeks, higher rates of improvement occurred with tofacitinib [42% to 59%] than placebo [9% to 11%], while adverse event rates were similar overall; ALT elevations above 3 times ULN occurred in 0.6% vs 0.2% of patients).
Genovese MC, Kremer J, Zamani O, Ludivico C, Krogulec M, Xie L, Beattie SD, et al. (2016). Baricitinib in patients with refractory rheumatoid arthritis. N Engl J Med. (Among 527 patients with rheumatoid arthritis refractory to tumor necrosis factor inhibitors who were treated with baricitinib [2 or 4 mg] or placebo daily for 24 weeks, clinical response rates were higher with baricitinib as were adverse events [61% and 67% vs 55%], including mild and transient ALT elevations [14% and 17% vs 10%], but no patient developed ALT elevations over 5 times ULN or suffered a liver related serious adverse event).
Papp KA, Menter MA, Raman M, Disch D, Schlichting DE, Gaich C, Macias W, et al. (2016). A randomized phase 2b trial of baricitinib, an oral Janus kinase (JAK) 1/JAK2 inhibitor, in patients with moderate-to-severe psoriasis. Br J Dermatol. (Among 271 patients with plaque psoriasis treated with baricitinib [2, 4, 8 or 10 mg] or placebo daily for 12 weeks, clinical responses were more frequent with baricitinib, particularly with higher doses while adverse event rates [including ALT elevations] were similar in all groups).
Markham A. (2017). Baricitinib: first global approval. Drugs. (Review of the development of baricitinib, its clinical efficacy and safety mentions that of 3464 patients treated in prelicensure clinical trials 6% developed adverse events leading to drug discontinuation, 3.4% developed herpes zoster, 3.2% serious infections, 0.7% malignancies and 0.3% died; aminotransferase elevations arose in 1.4% of patients but “most cases were transient”).
Taylor PC, Keystone EC, van der Heijde D, Weinblatt ME, Del Carmen Morales L, Reyes Gonzaga J, et al. (2017). Baricitinib versus placebo or adalimumab in rheumatoid arthritis. N Engl J Med. (Among 1307 patients with rheumatoid arthritis receiving methotrexate, addition of baricitinib led to higher clinical response rates than did adalimumab or placebo, while adverse event rates were higher with active therapies and ALT elevations arose in 27% on baricitinib, 24% on adalimumab vs 17% on placebo, but were above 5 times ULN in 1% or less in all three groups).
Dougados M, van der Heijde D, Chen YC, Greenwald M, Drescher E, Liu J, Beattie S, et al. (2017). Baricitinib in patients with inadequate response or intolerance to conventional synthetic DMARDs: results from the RA-BUILD study. Ann Rheum Dis. (Among 684 patients with rheumatoid arthritis refractory to DMARDs treated with baricitinib [2 or 4 mg] or placebo daily for 24 weeks, clinical response rates were higher with baricitinib while serious adverse event rates were similar, although mean changes in ALT levels were greater with baricitinib [+6 U/L] and adalimumab [+5 U/L] than with placebo [+1 U/L]).
Fleischmann R, Schiff M, van der Heijde D, Ramos-Remus C, Spindler A, Stanislav M, Zerbini CA, et al. (2017). Baricitinib, methotrexate, or combination in patients with rheumatoid arthritis and no or limited prior disease-modifying antirheumatic drug treatment. Arthritis Rheumatol. (Among 588 patients with rheumatoid arthritis treated with baricitinib or methotrexate or the combination, clinical response rates were highest in patients receiving baricitinib while ALT elevations arose in 33% on methotrexate alone, 16% on baricitinib alone and 34% on both, but ALT values above 5 times ULN were rare occurring in 1% or less and there were no severe hepatic adverse events).
Sanchez GAM, Reinhardt A, Ramsey S, Wittkowski H, Hashkes PJ, Berkun Y, Schalm S, et al. (2018). JAK1/2 inhibition with baricitinib in the treatment of autoinflammatory interferonopathies. J Clin Invest. (Among 18 patients with various interferon mediated autoinflammatory conditions treated with baricitinib for an average of 3 years, all except 5 had marked improvements in clinical symptoms and signs; no mention of ALT elevations or hepatotoxicity).
Keystone EC, Genovese MC, Schlichting DE, de la Torre I, Beattie SD, Rooney TP, Taylor PC. (2018). Safety and efficacy of baricitinib through 128 weeks in an open-label, longterm extension study in patients with rheumatoid arthritis. J Rheumatol. (Among 301 patients enrolled in a controlled trial of baricitinib [2, 4, or 8 mg daily] for 24 weeks [Keystone 2015], 171 entered an open label extension study [4 or 8 mg daily], and 133 completed 128 weeks of treatment, among whom ALT elevations occurred in approximately 25% but were above 5 times ULN in 1% or less; one patient developed a self-limited acute hepatitis B that was thought to be nosocomially acquired and unrelated to therapy).
Guttman-Yassky E, Silverberg JI, Nemoto O, Forman SB, Wilke A, Prescilla R, et al. (2019). Baricitinib in adult patients with moderate-to-severe atopic dermatitis: a phase 2 parallel, double-blinded, randomized placebo-controlled multiple-dose study. J Am Acad Dermatol. (Among 124 adults with atopic dermatitis treated with baricitinib [2 or 4 mg] or placebo daily for 16 weeks, clinical response rates were higher with baricitinib [57% and 61% vs 37%] as were adverse event rates [46% and 71% vs 49%]; no mention of ALT elevations or hepatotoxicity).
(2018). Drugs for rheumatoid arthritis. Med Lett Drugs Ther. (Review of drugs for rheumatoid arthritis mentions that baricitinib is an orally available, small molecule inhibitor of JAK kinases and that its potential adverse side effects include serum ALT elevations).
(2018). Baricitinib (olumiant) for rheumatoid arthritis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of baricitinib shortly after its approval for use in rheumatoid arthritis in the US, mentions that elevations in liver enzymes have been reported to occur).
Wallace DJ, Furie RA, Tanaka Y, Kalunian KC, Mosca M, Petri MA, Dörner T, et al. (2018). Baricitinib for systemic lupus erythematosus: a double-blind, randomised, placebo-controlled, phase 2 trial. Lancet. (Among 314 adults with systemic lupus erythematosus treated with baricitinib [2 or 4 mg] or placebo once daily for 24 weeks, clinical improvements arose in 53% on placebo versus 58% and 67% on baricitinib while adverse events were more frequent with study drug; while there were no “clinically meaningful differences in laboratory abnormalities”, ALT levels above 3 times ULN arose in 1.9% on placebo versus 4.8% on 4 mg but none on 2 mg of baricitinib daily, and there were no severe hepatic adverse events).
Smolen JS, Genovese MC, Takeuchi T, Hyslop DL, Macias WL, Rooney T, Chen L, et al. (2019). Safety profile of baricitinib in patients with active rheumatoid arthritis with over 2 years median time in treatment. J Rheumatol. (Analysis of adverse effects of baricitinib in 8 controlled trials and one long term extension study of rheumatoid arthritis included data on 3492 patients followed for a median of 2.1 years found an increased rate of infections with baricitinib 2 mg and 4 mg daily vs placebo [84 and 88.4 vs 75.9 per 100 patient-yrs], 10 cases of tuberculosis [all with 4 mg daily] and increased rate of herpes zoster [3.1 and 4.3 vs 1.0 per 100 patient-years]; no mention of ALT elevations or hepatotoxicity: see Winthrop 2020).
Richardson P, Griffin I, Tucker C, Smith D, Oechsle O, Phelan A, Rawling M, et al. (2020). Baricitinib as potential treatment for 2019-nCoV acute respiratory disease. Lancet. (Using artificial intelligence, pathways of SARS-CoV-2 were defined and agents known to inhibit those enzymes were sought, an impressive candidate being baricitinib which inhibits AAK1 which mediates the transfer of SARS-CoV19 ).
Harigai M, Winthrop K, Takeuchi T, Hsieh TY, Chen YM, Smolen JS, Burmester G, et al. (2020). Evaluation of hepatitis B virus in clinical trials of baricitinib in rheumatoid arthritis. RMD Open. (Among 215 patients with anti-HBc without HBsAg treated with baricitinib [2 or 4 mg daily] in preregistration trials, 32 developed detectable HBV DNA during treatment, but levels were low (usually less than 100 IU/mL, transient and not associated with ALT elevations, symptoms or jaundice).
Winthrop KL, Harigai M, Genovese MC, Lindsey S, Takeuchi T, Fleischmann R, Bradley JD, et al. (2020). Infections in baricitinib clinical trials for patients with active rheumatoid arthritis. Ann Rheum Dis. (Analysis of adverse effects of baricitinib in 8 controlled trials and one long term extension study in rheumatoid arthritis included data on 3492 patients followed for a median of 2.6 years and found an increased rate of infections with baricitinib 2 mg and 4 mg daily vs placebo [84 and 88.4 vs 75.9 per 100 patient-yrs], 11 cases of tuberculosis [all with 4 mg daily] and increased rate of herpes zoster [3.1 and 4.3 vs 1.0 per 100 patient-years]; no mention of ALT elevations or hepatotoxicity: see Smolen 2019 ).
Peng L, Xiao K, Ottaviani S, Stebbing J, Wang YJ. (2020). A real-world disproportionality analysis of FDA Adverse Event Reporting System (FAERS) events for baricitinib. Expert Opin Drug Saf. (Analysis of the FDA Adverse Event Reporting System from 2018 to 2020 identified 1598 reports on baricitinib, the topic area reporting odds ratio [ROR] being highest and statistically significant for infections [n=464, ROR=3.0] and hepatobiliary disorders [n=84, ROR=2.0] which included specific terms of hepatocellular injury in 17, cholestasis 7, hepatitis 7, liver injury 5 and steatosis 5).
Raschi E, Caraceni P, Poluzzi E, De Ponti F. (2020). Baricitinib, JAK inhibitors and liver injury: a cause for concern in COVID-19?. Expert Opin Drug Saf. (Letter in response to Peng et al [2020] stressing the need to assess the potential hepatotoxicity of baricitinib in human trials).
Jorgensen SCJ, Tse CLY, Burry L, Dresser LD. (2020). Baricitinib: a review of pharmacology, safety, and emerging clinical experience in COVID-19. Pharmacotherapy. (Review of the mechanisms of action and potential antiviral and anticytokine actions of baricitinib that make it a candidate therapy for COVID-19 infection including its inhibition of pathways in interferon alpha signaling and cytokine induction; mentions that serum aminotransferase elevations have been reported in humans receiving baricitinib for SARS-CoV-2 infection).
Titanji BK, Farley MM, Mehta A, Connor-Schuler R, Moanna A, Cribbs SK, O'Shea J, et al. (2021). Use of baricitinib in patients with moderate to severe Coronavirus Disease 2019. Clin Infect Dis. (Among 15 patients hospitalized with severe COVID-19 treated with hydroxychloroquine and baricitinib [2 or 4 mg daily] for an average of 5 days [range 1 to 7], 12 improved and 3 died; no mention of hepatic complications; ALT levels averaged 52 U/L before [range 16-126] vs 68 U/L after [range 13-180] therapy).
Sodani P, Mucci L, Girolimetti R, Tedesco S, Monaco F, Campanozzi D, Brunori M, et al. (2020). Successful recovery from COVID-19 pneumonia after receiving baricitinib, tocilizumab, and remdesivir. A case report: Review of treatments and clinical role of computed tomography analysis. Respir Med Case Rep. (50 year old man with severe COVID-19 pneumonia was treated initially with hydroxychloroquine and azithromycin followed by baricitinib and then tocilizumab and corticosteroids, and finally remdesivir, after which there was slow but steady recovery).
Reich K, Kabashima K, Peris K, Silverberg JI, Eichenfield LF, Bieber T, Kaszuba A, et al. (2020). Efficacy and safety of baricitinib combined with topical corticosteroids for treatment of moderate to severe atopic dermatitis: a randomized clinical trial. JAMA Dermatol. (Among 329 adults with atopic dermatitis treated with baricitinib [2 or 4 mg daily] vs placebo for 16 weeks, itching decreased with baricitinib therapy, and no patient had ALT elevations greater than 3 times ULN during therapy).
Bieber T, Thyssen JP, Reich K, Simpson EL, Katoh N, Torrelo A, De Bruin-Weller M, et al. (2021). Pooled safety analysis of baricitinib in adult patients with atopic dermatitis from 8 randomized clinical trials. J Eur Acad Dermatol Venereol. (Analysis of safety data from 6 controlled trials and 3 extension studies of baricitinib in 2531 patients with atopic dermatitis found no greater rates of severe infections or opportunistic infections but slight increase in rates of herpes zoster with baricitinib compared to placebo therapy; ALT elevations of 3 times ULN or above occurred in 1.0% of placebo vs 1.6% of baricitinib treated subjects and was above 5 times ULN in 0.1% vs 0.2%, one treated subject having ALT levels above 10 times ULN, but none with clinically apparent liver injury with jaundice).
Reich K, DeLozier AM, Nunes FP, Thyssen JP, Eichenfield LF, Wollenberg A, Ross Terres JA, et al. (2022). Baricitinib improves symptoms in patients with moderate-to-severe atopic dermatitis and inadequate response to topical corticosteroids: patient-reported outcomes from two randomized monotherapy phase III trials. J Dermatolog Treat. (Combined analysis of 2 randomized controlled trials of baricitinib [2 or 4 mg] versus placebo is 1239 adults with atopic dermatitis reported decreases in severity of itch and skin pain and improvements in sleep and quality of life with baricitinib compared to placebo in both trials; no discussion of adverse events or ALT levels).
Stebbing J, Sánchez Nievas G, Falcone M, Youhanna S, Richardson P, Ottaviani S, Shen JX, et al. (2021). JAK inhibition reduces SARS-CoV-2 liver infectivity and modulates inflammatory responses to reduce morbidity and mortality. Sci Adv. (Among 83 patients hospitalized with COVID-19 and treated with baricitinib in 2 European centers who were propensity matched with 83 controls from the same centers and time period, death or need for mechanical ventilation occurred in 17% of baricitinib vs 35% of control subjects, the effect being seen within 5 days and persisting after treatment; ALT elevations above 2 times ULN arose in 15 [18%] but were self-limited and not associated with symptoms or jaundice; in vitro studies demonstrated that baricitinib prevented interferon alfa-induced increased gene expression and increase in SARS-CoV-2 receptor, suggesting an antiviral as well as anti-cytokine effect).
Valor-Méndez L, Voskens C, Rech J, Kleyer A, Schett G. (2021). Herpes simplex infection in a patient with rheumatoid arthritis treated with baricitinib: a case report. Rheumatology (Oxford). (56 year old woman with rheumatoid arthritis in remission on methotrexate and baricitinib for 1 year stopped therapy for 1 week for elective surgery and then developed severe herpes simplex shortly after restarting and was switched to abatacept and methotrexate after acyclovir therapy and recovery).
Rodriguez-Garcia JL, Sanchez-Nievas G, Arevalo-Serrano J, Garcia-Gomez C, Jimenez-Vizuete JM, Martinez-Alfaro E. (2021). Baricitinib improves respiratory function in patients treated with corticosteroids for SARS-CoV-2 pneumonia: an observational cohort study. Rheumatology (Oxford). (Among 387 patients with moderate-to-severe COVID-19 pneumonia treated with methylprednisolone with [n=117] or without baricitinib [n=270], of which 62 receiving baricitinib had more rapid improvements in pulse oximetry-measured oxygen saturation than did a matched group of 50 receiving corticosteroids alone but without differences in rates of ICU admission or death; no mention of hepatotoxicity or ALT elevations).
Cantini F, Niccoli L, Matarrese D, Nicastri E, Stobbione P, Goletti D. (2020). Baricitinib therapy in COVID-19: A pilot study on safety and clinical impact. J Infect. (Among 12 adults with COVID-19 pneumonia not requiring intubation treated with baricitinib and lopinavir/ritonavir for two weeks, mean levels of symptoms, CRP and Sp02 improved, unlike 12 historic controls among whom they changed little; one treated patient developed ALT elevations peaking at 298 U/L and had therapy discontinued early [10 days]).
Cantini F, Niccoli L, Nannini C, Matarrese D, Natale MED, Lotti P, Aquilini D, et al. (2020). Beneficial impact of Baricitinib in COVID-19 moderate pneumonia; multicentre study. J Infect. (A retrospective analysis identified 113 patients with moderate COVID-19 pneumonia admitted to 4 Italian medical centers who were treated with baricitinib and lopinavir/ritonavir for 2 weeks; baricitinib treated patients had more rapid improvement in symptoms, SpO2 and CRP levels than 78 historical controls, and adverse events were mild but included 4 patients with serum ALT elevations on therapy; no details given).
Bronte V, Ugel S, Tinazzi E, Vella A, De Sanctis F, Canè S, Batani V, et al. (2020). Baricitinib restrains the immune dysregulation in patients with severe COVID-19. J Clin Invest. (Among 78 patients with COVID-19 pneumonia, the 20 who received baricitinib had greater degrees of clinical improvements and greater decreases in serum IL-6, ILIβ and TNFα levels during therapy).
FDA. https://www.fda.gov/media/143823/download (FDA fact sheet on use of baricitinib in combination with remdesivir for severe COVID-19 based upon an Emergency Use Authorization of November 19, 2020, with information on indications, drug dosage, adverse events, recommendations for monitoring and management of complications).
(2020). An EUA for baricitinib (Olumiant) for COVID-19. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of baricitinib shortly after its emergency use authorization as therapy of hospitalized patients with moderate-to-severe COVID-19 pneumonia mentions that side effects of baricitinib can include serious infections, thromboembolic effects, hypersensitivity reactions and serum aminotransferase elevations).
Rodriguez-Garcia JL, Sanchez-Nievas G, Arevalo-Serrano J, Garcia-Gomez C, Jimenez-Vizuete JM, Martinez-Alfaro E. (2021). Baricitinib improves respiratory function in patients treated with corticosteroids for SARS-CoV-2 pneumonia: an observational cohort study. Rheumatology (Oxford). (Among 112 hospitalized patients with COVID 19 and respiratory failure, improvement in SpO2 was greater and need for supplementary oxygen was less at the time of discharge in 62 patients who received baricitinib and methylprednisolone versus 50 who received methylprednisolone alone and adverse events were similar; no mention of ALT elevations or hepatotoxicity).
Peterson D, Damsky W, King B. (2020). The use of Janus kinase inhibitors in the time of severe acute respiratory syndrome coronavirus 2 (SARS-CoV-2). J Am Acad Dermatol. (Letter expressing caution about use of Janus kinase inhibitors during COVID-19 infection based upon their mechanism of action in blocking intracellular signaling pathways mediated by Janus kinases, but also mentioning 3 patients with alopecia areata who developed COVID-19 infection while on an inhibitor and had a relative mild, normal course of infection).
Satarker S, Tom AA, Shaji RA, Alosious A, Luvis M, Nampoothiri M. (2021). JAK-STAT pathway inhibition and their implications in COVID-19 therapy. Postgrad Med. (Review of the mechanism of action and pleomorphic activities of Janus kinase inhibitors and their possible role in treating severe COVID-19 infection which is often accompanied by high levels of proinflammatory cytokines [cytokine storm], with listing of ongoing trials including several of ruxolitinib).
Wong HS, Guo CL, Lin GH, Lee KY, Okada Y, Chang WC. (2021). Transcriptome network analyses in human coronavirus infections suggest a rational use of immunomodulatory drugs for COVID-19 therapy. Genomics. (Analysis of the temporal pattern of upregulation of genes in cells infected with SARS-CoV-2 suggest that medications most likely to affect these changes include among others dexamethasone, baricitinib, tofacitinib, sarilumab, ritonavir, naproxen, avelumab, durvalumab and atezolizumab).
Banerjee A, Goswami RP, Chatterjee M. (2021). Network theoretic analysis of JAK/STAT pathway and extrapolation to drugs and viruses including COVID-19. Sci Rep. (A theoretic analysis of the pathways affected by various rheumatologic medications and pathways affected by viral infections suggests that baricitinib would have the highest likelihood of efficacy in SARS-CoV-2 infection with lower efficacy of the other Janus kinase inhibitors, tofacitinib and ruxolitinib).
Kalil AC, Patterson TF, Mehta AK, Tomashek KM, Wolfe CR, Ghazaryan V, Marconi VC, et al., ACTT-2 Study Group Members. (2021). Baricitinib plus remdesivir for hospitalized adults with Covid-19. N Engl J Med. (Among 1033 patients hospitalized with COVID-19 pneumonia treated with remdesivir and either baricitinib or placebo for up to 14 days, the median time to recovery was faster with baricitinib than placebo [6 vs 7 days] and adverse event rates were lower; serum aminotransferase elevations arising in 1.8% vs 3.1% and to above 5 times ULN in only one baricitinib treated patient).
Calabrese LH, Calabrese C. (2021). Baricitinib and dexamethasone for hospitalized patients with COVID-19. Cleve Clin J Med. (Commentary on the controlled trials of remdesivir, dexamethasone and baricitinib for moderate-to-severe COVID-19 pneumonia mentions that the observed effects of baricitinib when combined with remdesivir have been modest [a one day shortening of recovery time] and there have been no trials comparing baricitinib and dexamethasone which appears to have a major effect on outcome of severe COVID-19 pneumonia).
Rodríguez-Tajes S, Miralpeix A, Costa J, López-Suñé E, Laguno M, Pocurull A, Lens S, et al. (2021). Low risk of hepatitis B reactivation in patients with severe COVID-19 who receive immunosuppressive therapy. J Viral Hepat. (Among 61 patients with severe COVID-19 who received immunomodulatory therapy [corticosteroids in 100%, tocilizumab in 72%, baricitinib in 3%] and were HBsAg negative but anti-HBc positive, 38 were given antiviral prophylaxis with entecavir and 23 were not, but none developed HBV reactivation, although 2 [no prophylaxis, anti-HBs negative] developed transient low levels of HBV DNA [<10 IU/mL] without aminotransferase elevations).
Wong HS, Guo CL, Lin GH, Lee KY, Okada Y, Chang WC. (2021). Transcriptome network analyses in human coronavirus infections suggest a rational use of immunomodulatory drugs for COVID-19 therapy. Genomics. (Analysis of the temporal pattern of upregulation of genes in cells infected with SARS-CoV-2 suggest that medications most likely to affect these changes include among others dexamethasone, baricitinib, tofacitinib, sarilumab, ritonavir, naproxen, avelumab, durvalumab and atezolizumab).
King B, Maari C, Lain E, Silverberg JI, Issa M, Holzwarth K, Brinker D, et al. (2021). Extended safety analysis of baricitinib 2 mg in adult patients with atopic dermatitis: an integrated analysis from eight randomized clinical trials. Am J Clin Dermatol. (Pooled analysis of 6 controlled trials and 2 extension studies of baricitinib in 1598 patients with atopic dermatitis found adverse events more frequent with drug than placebo [58% vs 52%], but severe adverse event rates were less frequent [1.6% vs 2.7%] with infections in 34% vs 28%, herpes simplex in 3.8% vs 2.8%, ALT elevations above 3 times ULN in 0.7% vs 1.0% and above 5 times ULN in 0.1% vs 0.1% with no hepatic severe adverse events).
Gatti M, Turrini E, Raschi E, Sestili P, Fimognari C. (2021). Janus kinase inhibitors and coronavirus disease (COVID)-19: rationale, clinical evidence and safety issues. Pharmaceuticals (Basel). (Review of the theoretic basis for use of JAK inhibitors in COVID-19 disease, clinical efficacy and safety of baricitinib and ruxolitinib mentions rare instances of ALT elevations and one case of drug induced liver injury).
(2021). Drugs for rheumatoid arthritis. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, toxicity and costs of drugs used to treat rheumatoid arthritis including baricitinib, tofacitinib and upadacitinib, common adverse events of which are gastrointestinal symptoms, nasopharyngitis and headache while aminotransferase elevations can occur as well as dyslipidemia and cytopenias; rare adverse events may include major adverse cardiovascular events, thrombosis, malignancy and increase risk of death).
Valor-Méndez L, Manger B, Schett G, Kleyer A. (2021). Hepatitis-E-virus-infektion bei einem patienten mit rheumatoider arthritis unter baricitinib-therapie. Z Rheumatol. (71 year old man with rheumatoid arthritis was found to have abnormal liver tests having been on baricitinib for several months, which was promptly stopped [ALT 2112 U/L, Alk P and bilirubin not given], but subsequent testing revealed presence of HEV RNA and IgM anti-HEV indicative of acute hepatitis E and baricitinib was restarted without recurrence of liver abnormalities).
Raghuvanshi R, Bharate SB. (2022). Recent developments in the use of kinase inhibitors for management of viral infections. J Med Chem. (Review of the kinase inhibitors approved for use in the US, their mechanisms of action and possible role in inhibiting viral replication).
Taylor PC, Takeuchi T, Burmester GR, Durez P, Smolen JS, Deberdt W, Issa M, et al. (2022). Safety of baricitinib for the treatment of rheumatoid arthritis over a median of 4.6 and up to 9.3 years of treatment: final results from long-term extension study and integrated database. Ann Rheum Dis. (Among 3770 patients with rheumatoid arthritis treated with baricitinib in registration trials and followed for up to 9 years [median 4.6 years], adverse events arose in 23%, serious adverse events 7.4%, herpes zoster 3.0%, major infections 2.6%, major adverse cardiovascular events [0.5%], and malignancy [0.9]; no mention of liver related adverse events).
Yip TC, Gill M, Wong GL, Liu K. (2022). Management of hepatitis B virus reactivation due to treatment of COVID-19. Hepatol Int. (Review of reactivation of HBV from drugs used to treated COVID-19 including corticosteroids, tocilizumab, sarilumab, and baricitinib, which despite the risk has not been documented to occur, perhaps due to the competing viral infection and short duration of therapy).
Bieber T, Reich K, Paul C, Tsunemi Y, Augustin M, Lacour JP, Ghislain PD, et al., BREEZE-AD4 study group. (2022). Efficacy and safety of baricitinib in combination with topical corticosteroids in patients with moderate-to-severe atopic dermatitis with inadequate response, intolerance or contraindication to ciclosporin: results from a randomized, placebo-controlled, phase III clinical trial (BREEZE-AD4). Br J Dermatol. (Among 463 patients with moderate-to-severe, refractory atopic dermatitis treated with baricitinib [1, 2 or 4 mg] or placebo daily for 52 weeks, at week 16 responses were highest with the higher doses [37%, 29% and 27% vs 19% with placebo], and adverse events were also greatest with higher doses including serious adverse events [11%], infections [73%], herpes zoster [3.3%], although there “no meaningful differences in liver enzymes between treatment groups”).
Hoisnard L, Lebrun-Vignes B, Maury S, Mahevas M, El Karoui K, Roy L, Zarour A, et al. (2022). Adverse events associated with JAK inhibitors in 126,815 reports from the WHO pharmacovigilance database. Sci Rep. (Among 126,815 individual case safety reports on ruxolitinib, tofacitinib and baricitinib made to the WHO pharmacovigilance registry, infections were most frequent including viral, fungal, bacterial and mycobacterial complications while there was no increase in hepatobiliary reports).
King B, Ohyama M, Kwon O, Zlotogorski A, Ko J, Mesinkovska NA, Hordinsky M, et al. (2022). BRAVE-AA Investigators. Two phase 3 trials of baricitinib for alopecia areata. N Engl J Med. (Among 1200 patients with alopecia areata treated with baricitinib or placebo once daily for 36 weeks in two controlled trials, clinical responses were higher with 4 mg [39% and 36%], than with 2 mg [23% and 19%], or placebo [6.2% and 3.3%] while adverse event rates were similar in all 3 groups, and ALT elevations above 3 times ULN were less frequent with baricitinib [1.5% vs 2.7%]).
Wolfe CR, Tomashek KM, Patterson TF, Gomez CA, Marconi VC, Jain MK, Yang OO, et al., ACTT-4 Study Group. (2022). Baricitinib versus dexamethasone for adults hospitalised with COVID-19 (ACTT-4): a randomised, double-blind, double placebo-controlled trial. Lancet Respir Med. (Among 1010 patients hospitalized with COVID-19 on supplemental oxygen who were treated with remdesivir and either baricitinib [4 mg daily] or dexamethasone, survival to day 29 without need of mechanical ventilation was similar in the two groups [87.0% vs 87.5%] as was mortality rates [5.5% vs 6.4%], but adverse events were less frequent with baricitinib [30% vs 37%], while serious adverse event rates were similar [19% vs 20%] and ALT elevations arose in less than 1% of both groups).
RECOVERY Collaborative Group. (2022). Baricitinib in patients admitted to hospital with COVID-19 (RECOVERY): a randomised, controlled, open-label, platform trial and updated meta-analysis. Lancet. (Among 8156 patients enrolled in an open label platform trial in patients hospitalized with COVID-19, mortality was 12% baricitinib vs 14% with usual care and there were “no safety concerns”).
Shawky AM, Almalki FA, Abdalla AN, Abdelazeem AH, Gouda AM. (2022). A comprehensive overview of globally approved JAK inhibitors. Pharmaceutics. (Review of the JAK-STAT pathways and currently approved JAK inhibitors; JAK proteins are cytoplasmic, non-receptor tyrosine kinases involved in transduction of cytokine signals that pair when binding to transmembrane cytokine receptors and, once activated, phosphorylate STAT causing its dimerization and transfer to the nucleus where it activates cytokine induced genes).
Wood H, Chandler A, Nezamololama N, Papp K, Gooderham MJ. (2022). Safety of Janus kinase (JAK) inhibitors in the short-term treatment of atopic dermatitis. Int J Dermatol. (Review of the safety of JAK inhibitors including abrocitinib, baricitinib, upadacitinib, and ruxolitinib mentions that common adverse events are headache [5-10%], nausea [2-20%], transient thrombocytopenia, herpes simplex [0-7%] and herpes zoster [0-2%]; no mention of ALT elevations or hepatotoxicity).
Yip TC, Gill M, Wong GL, Liu K. (2022). Management of hepatitis B virus reactivation due to treatment of COVID-19. Hepatol Int. (Review of published data on reactivation of hepatitis B caused by treatment of COVID focusing upon corticosteroids, baricitinib, tofacitinib, sarilumab and tocilizumab, which are capable of inducing reactivation when used in rheumatic disease, but have not been reported with their use for COVID-19 perhaps due to duration of therapy or the heightened immune activity of the viral infection).

## OTHER REFERENCE LINKS

1 Recent References on Baricitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Baricitinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Baricitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Baricitinib)